# Tinospora

## OVERVIEW

### Introduction

Tinospora cordifolia is an herbaceous climbing shrub native to India and South Asia, extracts of leaves, roots and bark of which have been used extensively in traditional Indian (Ayurveda) medicine for a multitude of conditions including diabetes, arthritis, liver diseases, malaria, pain, urinary tract infection, and recently prevention or amelioration of COVID-19 infection. Several recent reports have documented the occurrence of clinically apparent liver injury with its long term use.

### Background

Tinospora cordifolia is a climbing herbaceous vine found in the subtropical rainforests of India, South Asia, and Africa. Extracts of its bark, roots, and leaves have been used in traditional Indian (Ayurveda) medicine for centuries to treat a variety of conditions including diabetes, rheumatism, jaundice, malaria, asthma, depression, pain, and urinary tract infections. Known as Giloy in Hindi and Guduchi in Sanskrit, Tinospora cordifolia has been found to have possibly beneficial biologic activities in cell culture and in animal models including hypoglycemic, diuretic, antiinflammatory, antioxidant, analgesic, antimalarial, antiviral, hepatoprotective, immunomodulatory, and antineoplastic activities. Chemical analyses have demonstrated more than 60 compounds in Tinospora species including lactones, steroids, flavonoids, lignans, alkaloids, and most characteristically di- and mono-terpenes including the characteristic clerodane-type furanoditerpenoids. Recently, its purported immune boosting effects led to the proposal that it might be helpful in preventing severe COVID-19 infection. However, none of the claimed biologic or clinical activities of Tinospora that were demonstrated in animal studies have been shown in studies in humans. Nevertheless, it is widely available and is purported to activate immune function and restore immune health. Tinospora is available over-the-counter in various forms including solutions, powders, capsules, and tablets as well as raw, dried bark. Tinospora is present in several Ayurvedic combination products. The typical dose is 400 to 1000 mg daily. Side effects are uncommon but may include headache, dizziness, nausea, abdominal discomfort, diarrhea, and rash.

### Hepatotoxicity

In small rather short term clinical studies of different preparations and concentrations of Tinospora cordifolia, adverse side effects were usually described as uncommon and minimal with no mention of hepatotoxicity. Indeed, Tinospora cordifolia was purported to prevent hepatic injury and, unlike a similar genus, Tinospora crispa, to be without intrinsic hepatotoxicity. Despite these findings, descriptions of liver injury from T. cordifolia similar to those from T. crispa appeared which were initially dismissed as being due to incorrect identification of T. crispa as T. cordifolia. However, reports of more than 50 cases of clinically apparent acute liver injury have appeared since 2017 and particularly during the COVID-19 pandemic probably fueled by the suggestion that Tinospora cordifolia was an immune booster and might ameliorate or prevent clinically apparent COVID-19 infection. The cases were reported mostly from India and Thailand, but single cases were reported from Germany, Belgium, France and the United States. In addition to publications of more than 50 cases of T. cordifolia induced liver injury, there are at least 7 published cases attributed to T. crispa. The injury from both species was typically hepatocellular with ALT and AST values of 10 to 50 times the upper limit of normal (500 to 3000 U/L), minimal alkaline phosphatase and GGT elevations, and variable degrees of hyperbilirubinemia. The latency to onset ranged from a few weeks to 6 months. Immune allergic symptoms (fever and rash) occurred but were not common, while autoantibodies were frequent and sometimes accompanied by hyperglobulinemia and autoimmune features on liver biopsy. Several fatal cases with submassive hepatic necrosis have been described, most often in patients with preexisting liver disease.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

Tinospora cordifolia has multiple constituents and the chemical compound responsible for liver injury is not known, although thought to be a diterpenoid. The clinical features of Tinospora liver injury suggest that it is immunologically mediated. Cases appear to be more frequent and more severe in patients with preexisting liver disease and its immune boosting activities may be responsible for some of its toxicity.

### Outcome and Management

Cases of liver injury from Tinospora cordifolia have ranged in severity from minimally symptomatic elevations in serum aminotransferase levels to cases of mild hepatitis resolving rapidly upon stopping to severe hepatitis including acute liver failure leading to fatalities. Liver injury from Tinospora is typically self-limited in course and chronic injury has not been clearly described. However, many cases arise in patients with preexisting liver disease and present as acute-on-chronic liver injury, which can result in worsening of the underlying liver disease and evidence of chronic injury.

Drug Class: Herbal and Dietary Supplements

Other names: Giloy, Guduchi, Heart-leaved Moonseed

## CASE REPORT

### Case 1. Acute hepatitis with jaundice attributed to a multiingredient product containing Tinospora cordifolia, Butterbur, and Spirulina.(1)

A 59 year old Japanese woman with recurrent sinusitis developed fatigue and poor appetite followed by dark urine and jaundice approximately six weeks after starting a commercial multiingredient herbal product advertised as helpful for sinus support. She had no previous history of liver disease or risk factors for viral hepatitis and did not drink alcohol. She had many drug allergies, including responses to sulfa antibiotics, penicillin, tetracycline, and montelukast. Her other medical conditions (and medications) included hypertension (amlodipine, losartan), asthma (fluticasone), sinusitis (cetirizine), hyperlipidemia (atorvastatin), constipation (macrogol), obesity, and diabetes. She had taken her other medications chronically for many years. After 2 weeks of symptoms, she sought medical care and was found to be jaundiced. She was admitted for evaluation and the herbal product was stopped. Her laboratory tests showed a total serum bilirubin of 19.6 mg/dL, ALT 755 U/L, AST 696 U/L, alkaline phosphatase 173 U/L (R=7.1: hepatocellular). The INR was 1.4 and serum albumin 3.9 g/dL. Tests for hepatitis A, B, and C were negative. The ANA (1:40) and SMA (1:160) were positive, but the AMA was negative, and IgG levels were in the high normal range (1631 mg/dL). An abdominal ultrasound was normal without evidence of biliary obstruction or gallstones. The herbal product was stopped. Over the next several days, her bilirubin rose to 33.6 mg/dL and INR to 1.6 (Table). A liver biopsy showed acute hepatitis with bridging necrosis and collapse, but with minimal fibrosis and scant steatosis. There were dense portal lymphocytic infiltrates but few plasma cells. The tentative diagnosis was drug induced liver injury due to the multi-ingredient product which was labeled as having 4 ingredients: Indian Tinospora extract [450 mg], Stinging nettle powder [400 mg], Spirulina powder [30 mg], and petasins from Butterbur Extract [16 mg]. When seen in follow up, she slowly improved, and 6 and 9 months after onset, she was asymptomatic, and all liver tests were normal.

#### Key Points

Medication: | Tinospora cordifolia [400 mg daily], Likelihood score “A” Butterbur [16 mg daily], Likelihood score “C” Spirulina [30 mg daily], Likelihood score “D”
Pattern: | Hepatocellular (R=7.1)
Severity: | 4+ (jaundice, hospitalization, INR >1.5)
Latency: | ~6 weeks
Recovery: | Complete within 6 months
Other medications: | Atorvastatin, losartan, amlodipine, cetirizine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | Started multi-ingredient herbal product
6 weeks | -2 weeks | Developed symptoms of fatigue, nausea, jaundice
8 weeks | 0 | 755 | 173 | 19.6 | Admitted, agent stopped
| 6 days | 476 | 161 | 33.6 | INR 1.4
| 9 days | 334 | 129 | 33.5 | INR 1.6
10 weeks | 11 days | 267 | 118 | 31.8 | Liver biopsy
15 weeks | 51 days | 19 | | 3.3 | Outpatient visit
| 6 months | 10 | 104 | 1.0 | INR 1.0
| 9 months | 10 | 97 | 1.0
Upper Limit of Normal | | 70 | 115 | 1.2

#### Comment

A middle-aged woman developed acute, icteric hepatitis 6 weeks after starting a multiingredient herbal product for “sinus health”. The injury was scored as “severe” with bilirubin rising to above 30 mg/dL and INR to above 1.5. The severity may have been due partially to her delay in seeking medical care and continuation of the product for 2 weeks after onset of symptoms. She began to improve spontaneously a week and a half after stopping but remained jaundiced for almost two months. In long term follow up, she had recovered completely. The challenge in the case was to assign causality to a specific component because three of the ingredients have been implicated in causing liver injury, generally with a hepatocellular pattern and sometimes a severe course. This case was enrolled in the U.S. Drug-Induced Liver Injury Network and was judged to be “highly likely” due to the herbal product. Assigning the most likely causative ingredient to Tinospora was based on the higher dose and the frequency of reports in the literature. Thus, Tinospora has a LiverTox likelihood score of “A” (>50 reports in the literature), while butterbur has a “C” (4-11 case reports), and Spirulina a “D” (only 1 report).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tinospora cordifolia – Generic

DRUG CLASS

Herbal and Dietary Supplements

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clerodane Diterpenoids | 51773-71-8 | C20-H32 | SID: 135161005

## CITED REFERENCE

1 Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408.25043597

## ANNOTATED BIBLIOGRAPHY

References updated: 27 June 2025

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not Tinospora).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of Tinospora).
Tinospora. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 935-7. (Compilation of short monographs on herbal medications and dietary supplements).
Sangsuwan C, Udompanthurak S, Vannasaeng S, Thamlikitkul V. Randomized controlled trial of Tinospora crispa for additional therapy in patients with type 2 diabetes mellitus. J Med Assoc Thai. 2004;87:543-6. (Among 40 patients from Thailand with type 2 diabetes with inadequate responses to oral hypoglycemic agents and refusal to start insulin who were treated with Tinospora crispa [1 gm] or placebo 3 times daily for 6 months, fasting glucose, HgbA1c, and insulin levels did not change, while patients on the herbal therapy lost weight, had increases in serum cholesterol, and two [10%] had marked increases in serum ALT or AST [above 200 U/L] without symptoms or jaundice that resolved rapidly with stopping treatment [to less than 30 U/L]). 15222526
Denis G, Gérard Y, Sahpaz S, Laporte R, Viget N, Ajana F, Riff B, et al. Prophylaxie antipaludéenne par plantes médicinales: hépatite toxique à Tinospora crispa [Malarial prophylaxis with medicinal plants: toxic hepatitis due to Tinospora crispa]. Therapie. 2007;62:271-2. French. (37 year old man developed indigestion and fatigue 7 weeks after starting an herbal preparation of Tinospora crispa as prophylaxis against malaria while visiting in Indonesia [ALT 18 times ULN, GGT 4 times ULN, bilirubin levels not given], which resolved within a few weeks of stopping, chemical analysis demonstrating typical profile of T. crispa and the apparent dose being 3.2 gm daily). 17955597
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list Tinospora among products associated with 5 or more reports). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not Tinospora). 20949552
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not mention or list Tinospora). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies, but does not mention Tinospora). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to Tinospora). 25043597
Langrand J, Regnault H, Cachet X, Bouzidi C, Villa AF, Serfaty L, Garnier R, et al. Toxic hepatitis induced by a herbal medicine: Tinospora crispa. Phytomedicine. 2014;21:1120-3. (49 year old man developed abdominal pain, dark urine, and jaundice 4 weeks after starting Tinospora crispa for back pain [bilirubin 20.5 mg/dL, ALT 2029 U/L, Alk P 81 U/L], liver biopsy showing an acute hepatitis, and stopping the herb led to rapid improvement with normal liver tests within 2 months). 24867504
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss Tinospora). 27402097
Cachet X, Langrand J, Riffault-Valois L, Bouzidi C, Colas C, Dugay A, Michel S, et al. Clerodane furanoditerpenoids as the probable cause of toxic hepatitis induced by Tinospora crispa. Sci Rep. 2018;8:13520. (57 year old man from the French West Indies developed fever, fatigue, dark urine and jaundice 3 weeks after starting an extract of Tinospora crispa [bilirubin 2.0 mg/dL, ALT 1423 U/L, GGT 155 U/L], which resolved rapidly upon stopping; analysis of the extract demonstrated components compatible with T. crispa, among which furano-diterpenoids were considered the most likely causes of the injury). 30202067
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of Tinospora). 29307848
Huang WT, Tu CY, Wang FY, Huang ST. Literature review of liver injury induced by Tinospora crispa associated with two cases of acute fulminant hepatitis. Complement Ther Med. 2019;42:286-291. (Two Taiwanese men, ages 63 and 57, developed acute liver failure after taking Tinospora crispa daily for 1 week and 1 month [bilirubin 20 and 10 mg/dL, ALT >2000 and 1844 U/L], the first progressing to liver failure and death and the second ultimately recovering). 30670256
Karousatos CM, Lee JK, Braxton DR, Fong TL. Case series and review of Ayurvedic medication induced liver injury. BMC Complement Med Ther. 2021;21:91. (Three patients seen in Los Angeles developed acute hepatitis while taking Ayurvedic medications including a 68 year old South Asian woman who developed hepatitis 4 months after starting Tinospora cordifolia alone [bilirubin 1.0 rising to 3.7 mg/dL, ALT 1016 U/L, Alk P 113 U/L, INR 1.0, ANA weakly positive], resolving rapidly upon stopping; the other two patients developed a similar hepatitis, both after starting mixtures of Ayurvedic medicines, one of which included Tinospora cordifolia with 18 other agents). 33714265
Nagral A, Adhyaru K, Rudra OS, Gharat A, Bhandare S. Herbal immune booster-induced liver injury in the COVID-19 pandemic - A case series. J Clin Exp Hepatol. 2021;11:732-738. (Over a 4 month period during the COVID-19 pandemic, 6 patients were seen at a referral center in India with acute liver injury due to Tinospora cordifolia taken for COVID prophylaxis [mean peak bilirubin 17.5 mg/dL, ALT 1092 U/L, ANA positive in 3], biopsies demonstrating features of autoimmune hepatitis, all recovering after stopping, often receiving corticosteroid therapy). 34230786
Björnsson ES, Navarro VJ, Chalasani N. Liver injury following Tinospora cordifolia consumption: drug induced AIH, or de novo AIH? J Clin Exp Hepatol. 2022; 12: 6-9. (Editorial in response to Nagral [2021] mentions that the 6 patients with T. cordifolia-associated liver injury had clinical features of autoimmune hepatitis and that the resolution of injury upon withdrawal of the product indicated that it could be labelled as herb induced autoimmune-like hepatitis). 35068778
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; mentions two cases attributed to Tinospora crispa among the 79 implicated products). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while Tinospora was not mentioned). 33434654
Gupta S, Dhankhar Y, Har B, Agarwal S, Singh SA, Gupta AK, Saigal S, Jadaun SS. Probable drug-induced liver injury caused by Tinospora species: a case report. J Clin Exp Hepatol. 2022;12:232-234. (In a letter to the editor in response to the report by Nagral [2021], two cases of biopsy proven hepatitis possibly related to Tinospora cordifolia were described, laboratory results and outcomes not provided). 35068807
Kulkarni AV, Hanchanale P, Prakash V, Kalal C, Sharma M, Kumar K, Bishnu S, et al.; Liver Research Club India. Tinospora cordifolia (Giloy)-induced liver injury during the COVID-19 pandemic-multicenter nationwide study from India. Hepatol Commun. 2022;6:1289-1300. (Retrospective study from 13 Indian medical centers enrolled 43 patients with suspected Tinospora cordifolia induced hepatitis between April 2020 and July 2021, of whom half were women [54%], mean age 50.4 years, presenting with acute hepatitis [44%], acute worsening of chronic liver disease [51%], or acute liver failure [5%]; median initial bilirubin 11.7 mg/dL, ALT 281 U/L [range 56-1269 U/L], Alk P 215 U/L, INR 1.53, ANA positivity in 42%, leading to death in 4 and liver transplant in 2 patients). 35037744
May K, Jeitler M, Murthy V, Stapelfeldt E, Kessler CS. A case report of acute hepatitis involving the medicinal herb Tinospora cordifolia along with other variables. J Integr Complement Med. 2023;29:327-333. (54 year old German woman developed fatigue and nausea 3 months after starting Ayurvedic herbals including Tinospora cordifolia [bilirubin 2.0 mg/dL, ALT 2534 U/L, Alk P 137 U/L, GGT 218 U/L], resolving within 2-3 months of discontinuation). 36930784
Nnamani I, Tolu-Akinnawo O, Dufera RR, Akintunde A, Maliakkal B. Tinospora cordifolia (Guduchi/Giloy)-induced liver injury: a case review. Cureus. 2023;15:e39793. (50 year old woman in Nashville, TN developed abdominal pain 4-5 weeks after starting HistaEze, a Tinospora cordifolia extract containing product, in a dose of 900 mg daily as a means of preventing COVID infection [bilirubin 0.9 mg/dL, ALT 1336 U/L, Alk P 57 U/], resolving within 2-3 months of stopping). 37273324
Timmery E, Binet Q, Delire B, Horsmans Y. Acute hepatitis induced by Guduchi; Letter to the editor. Clin Res Hepatol Gastroenterol. 2023;47:102151. (61 year old Belgium woman developed nausea and anorexia 1 month after starting an herbal preparation of Guduchi [bilirubin 4.7 mg/dL, ALT 893 U/L, Alk P 153 U/L, INR 1.2], resolving within a month of stopping). 37269895
Singh PA, Bajwa N. Is Tinospora cordifolia responsible for drug-induced liver injury? Curr Drug Saf. 2024;19:8-10. (Commentary on the multiple publications implicating Tinospora cordifolia in cases of acute liver injury arguing that the species causing liver injury is not T. cordifolia but rather T. crispa, which was implicated in several cases of hepatitis similar to those in recent reports: “Time-tested herb, Giloy, which has been used for pharmacological benefits since antiquity, as well as clinical and toxicological evidence suggest that Giloy is safe, and the observed negative effects can be attributed to Tinospora crispa, a herb that resembles Tinospora cordifolia in appearance”). 36803756
Philips CA, Theruvath AH. A comprehensive review on the hepatotoxicity of herbs used in the Indian (Ayush) systems of alternative medicine. Medicine (Baltimore). 2024;103:e37903. (Extensive review of recent literature on traditional Indian herbs that have been linked to cases of liver injury including Tinosporia cordifolia [Giloy], Withania somnifera [Ashwagandha], Psoralea corylifolia [Bakuchi], and Curcuma longa [Turmeric]; arguing that careful phyto-chemical and DNA analyses have shown that T. cordifolia like T. crispa is associated with occasional instances of acute liver injury, possibly due to their distinctive clerodane-type furano-diterpenoids). 38640296

## OTHER REFERENCE LINKS

1. Recent References on Tinospora: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tinospora+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tinospora: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tinospora)